# Herbal and Dietary Supplements

## OVERVIEW

### Introduction

Herbal and dietary supplements (HDS) are commonly used by many people, both healthy and with specific ailments. The “well” HDS user often seeks to preserve health or promote a healthier lifestyle. The ailing HDS user seeks to supplement conventional therapies, hoping to achieve better health, or even to substitute for prescribed medications, with the perception that HDS are safe and as effective. It is estimated that over 40% of the U.S. population uses alternative therapies of some kind, most commonly HDS. Up to 40% of patients attending liver clinics also use supplements. Alarmingly, however, most patients who use HDS do not reveal this to their primary care provider. Moreover, it is not uncommon for providers to fail to ascertain a history of HDS use from their patients. Users of HDS tend to be Asians, younger, highly educated, and more health conscious than nonusers. The most common reasons for their use include obesity/weight loss, body building, menopausal symptoms, gastrointestinal disorders such as indigestion or constipation, liver disease, and neurological complaints such as headache and migraines.

### Background

Herbal and dietary supplements are considered foods, and are defined as products taken by mouth that contain a dietary ingredient intended to supplement the diet. These ingredients include vitamins, minerals, herbs and other botanicals, amino acids, enzymes, organ tissues, and metabolites. However, since HDS are not drugs, they are regulated differently than conventional pharmaceuticals. Under the Dietary Supplement Health and Education Act of 1994 (DSHEA) (https://www.fda.gov/Food/DietarySupplements/default.htm), manufacturers of HDS are responsible for the safety of their products, but need not have FDA approval before marketing. More recently, the Current Good Manufacturing Practices–Dietary Supplement Act (2007)–establishes the minimum standards for manufacturing, packaging, labeling, and holding, and is intended to ensure the identify, purity, quality, strength, and composition. Manufacturers are not required to conduct preclinical safety and efficacy assessments prior to marketing. The FDA’s specific responsibility is to determine if an HDS is unsafe, after which it can take action to recommend withdrawal from the market. Concern over a specific HDS or ingredient usually is triggered from reports of adverse events which may come from MEDWATCH or the manufacturer, which is statutorily compelled to alert the FDA of such events about which it becomes aware.

### Hepatotoxicity

The hepatotoxic potential of HDS has been recognized for many years. There are no reliable population-based statistics for the incidence of toxicity attributable to HDS in the United States, although the true incidence is likely to be very low. In the Drug Induced Liver Injury Network, HDS were implicated in approximately 10% of cases, but this rate appears to be increasing and most recently was more than 16% of cases. As discussed in the various HDS records within LiverTox, many single herbs have been implicated in liver toxicity. However, most currently available HDS comprise complex mixtures of ingredients and, although the FDA requires that a product label accurately reflect the contents, reports exist of product contamination and unlabeled ingredients. Reported contaminants include heavy metals, pharmaceuticals, microbial products, and pesticides. Further, HDS are vulnerable to variation in the quality or strength of ingredients, depending upon the time and conditions of harvest, as well as the part of the plant that is used for the product (for instance, leaf vs root vs. stem). Finally, analytical phytochemistry of HDS products implicated in causing liver injury often reveals adulteration of the product and sometimes mislabeling and absence of the botanical listed on the label and presence of a related or unrelated herbal that may be the hepatotoxic agent.

The diagnosis of HDS associated liver injury is predicated upon the usual principles of causality assessment, including establishing a chronology which implicates the HDS as having been taken before the onset of injury, exclusion of other causes of liver disease, and the response to withdrawal. The published experience with HDS associated liver toxicity is growing, but limited for many of the myriad available products. As in conventional pharmaceuticals, the confidence with which a diagnosis of liver injury is made depends, to a great extent, on the number of previously reported and published cases. Thus, time and experience will lead to more precise attribution of liver injury to HDS. Even for those HDS in which significant published experience on toxicity exists, the attribution of injury to a specific ingredient of the HDS is difficult, due to the complexity of the mixture. Arguably, the most surmountable obstacles to diagnosing HDS associated liver injury include the provider’s foresight in obtaining a complete supplement use history and the patient’s willingness to disclose their use.

Finally, chemical analysis of the implicated product can be very valuable in assigning causality, particularly for botanicals that have not been commonly implicated in causing liver disease as such analysis may identify the presence of a well established hepatotoxic agent. Examples of contaminants found in herbal preparations include germander in products labeled as being skullcap and various Asian Actaea in products labeled as black cohosh.

### Mechanism of Injury

The mechanism of liver injury due to HDS is, in the majority of cases, unknown. Most cases appear to be idiosyncratic and the clinical picture, including histology, is no different than that which is seen in conventional drug associated liver injury. However, some HDS are associated with a specific type of injury; for example, pyrrolizidine alkaloids which have been reported to lead to sinusoidal obstruction syndrome. As learned through the experience of the Drug Induced Liver Injury Network, it appears that most patients who sustain liver injury attributable to HDS manifest a hepatocellular pattern of injury.

### Outcome and Management

The principles of management of HDS associated liver injury are the same as those exercised for injury induced by conventional pharmaceuticals. Patients must be advised to cease all supplement use, and be monitored for signs of significant liver dysfunction. In the most severe circumstances, these signs include coagulopathy, encephalopathy, ascites, and jaundice. Most patients, however, may have mild or no symptoms associated with elevated liver enzymes. In these cases, it is no less important to advise the patient to stop HDS use, as limited experience in most cases, as well the factors which are unique to HDS (contamination, variability), prevent providers from predicting the course of liver injury with great confidence.

The following HDS products are specifically discussed in LiverTox.

- Aloe Vera
- Alpha Lipoic Acid
- Apoaequorin
- Areca Nut
- Arnica Montana
- Ashwagandha
- Astragalus
- Bacopa
- Bee Products
- Berberine
- Bilberry
- Bitter Melon
- Black Cohosh
- Black Cumin
- Boswellia
- Bromelain
- Buchu
- Butterbur
- Cascara
- Cat’s Claw
- Centella Asiatica
- Chamomile
- Chaparral
- Chaste Tree
- Chinese and Other Asian Herbal Medicines
  - Ba Jiao Lian
  - Chi R Yun
  - Jin Bu Huan
  - Ma Huang [Ephedra]
  - Polygonum Multiflorum
  - Sho Saiko To and Dai Saiko To
  - Shou Wu Pian
- Chondroitin
- Coenzyme Q10
- Comfrey
- Cordyceps
- Cranberry
- Crofelemer
- Dihydromyricetin
- Dragon’s Blood
- Echinacea
- Ephedra
- Eugenol
- Fenugreek
- Flavocoxid
- Garcinia Cambogia
- Germander
- Ginger
- Ginkgo
- Ginseng
- Glucosamine
- Grape Seed
- Greater Celandine
- Green Tea
- Guarana
- Gymnema
- Hawthorn
- Hoodia
- Hops
- Horny Goat Weed
- Horse Chestnut
- Horsetail
- Hyssop
- Kava
- Kelp
- Khat
- Kratom
- Lavender
- Lemon Balm
- Licorice
- Lingzhi, Reishi
- Lion’s Mane
- Maca
- Mahogany Seed
- Margosa Oil
- Melatonin
- Milk Thistle
- Mistletoe
- Moringa
- Noni
- Oregano
- Passionflower
- Pennyroyal Oil
- Quercetin
- Red Yeast Rice
- Resveratrol
- Saw Palmetto
- Senna
- Skullcap
- Slippery Elm
- Spirulina
- St. John's Wort
- Stinging Nettle
- Tara Flour
- Tinospora
- Tongkat Ali
- Tribulus
- Turmeric
- Usnic Acid
- Uva Ursi
- Valerian
- Yerba Mate
- Yohimbine
- Multi-Ingredient Nutritional Supplements
  - Herbalife
  - Hydroxycut
  - Move Free
  - OxyELITE Pro
  - SLIMQUICK

List updated: 01 July 2025

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Single author review of hepatotoxicity published in 1999; herbal medications covered in 3 pages at the end of a chapter on miscellaneous drugs, focusing on pyrrolizidine containing preparations, Chinese herbs, germander, chaparral, valerian, skullcap, amanita, and pennyroyal).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity published in 2007; HDS are covered in a 22 page chapter).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2013; HDS are covered in a 26 page chapter).
Larrey D. Hepatotoxicity of herbal remedies. J Hepatol 1997; 26 Suppl 1: 47-51. (Review of hepatotoxicity of herbals focusing upon pyrrolizidine alkaloids, germander and Chinese herbal medications). 9138129
Stickel F, Egerer G, Seitz HK. Hepatotoxicity of botanicals. Public Health Nutr 2000; 3: 113-24. (Review of hepatotoxicity of botanicals with specific discussion of Chinese herbals, germander, pyrrolizidine alkaloids, chaparral, and mushroom poisoning). 10948380
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review of HDS hepatotoxicity and description of patterns of liver injury, including discussion of clinical patterns, potential risk factors, and herb-drug interactions with specific discussion of pyrrolizidine alkaloids, germander, Chinese herbs, chaparral, greater celandine, pennyroyal, herbal laxatives, and kava). 12016550
De Smet PA. Herbal remedies. N Engl J Med 2002; 347: 2046-56. (Brief review of herbal remedies discussing their growing use, lack of regulation, problems of variability in content, quality, safety, potential adulterants and adverse events including hepatotoxicity, efficacy and special needs for prospective randomized controlled trials to define these factors; specific discussion of hawthorn, saw palmetto, gingko and St. John's Wort). 12490687
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Review of HDS associated hepatotoxicity, including common patterns of presentation and specific discussion of pyrrolizidine alkaloids, chaparral, germander, pennyroyal, skullcap, valerian, kava, Chinese herbals, greater celandine, and Lipokinetix). 12879994
Pittler MH, Ernest E. Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther 2003; 18: 451-71. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal oil [1], skullcap [2], Chinese herbs [9], valerian [1]). 12950418
Pak E, Esrason KT, Wu VH. Hepatotoxicity of herbal remedies: an emerging dilemma. Prog Transplant 2004; 14: 91-6. (Review of hepatotoxicity of herbal medications stressing the recent rise in numbers of cases, with literature review of comfrey, chaparral, germander, Ma Huang, Jin Bu Huan, greater celandine, cascara, kava and St. John’s wort). 15264453
Myers SP, Cheras PA. The other side of the coin: safety of complementary and alternative medicine. Med J Aust 2004; 181: 222-5. (Review of hepatotoxicity of herbal medications discussing their rising use in Australia and the problems of quality and safety, separating adverse events into "predictable" reactions and "idiosyncratic" reactions and stressing the need for further research, regulation and patient education). 15310261
Lenz TL, Hamilton WR. Supplemental products used for weight loss. J Am Pharm Assoc. 2004; 44: 59-67. (At least 50 herbal and dietary supplements have been promoted for weight loss, but none have strong clinical evidence of efficacy and several are toxic [ephedra and green tea]). 14965155
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications). 15390328
Stickel F, Patsenker E, Schuppan D. Herbal hepatotoxicity. J Hepatol 2005; 43: 901-10. (Topical review, highlighting Chinese herbs, pyrrolizidine alkaloids, germander, greater celandine, kava, and chaparral, among others; insights on diagnosis and management are offered). 16171893
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. 2005; 129: 512-21. (Reports of drug induced liver injury to a Spanish network: among 570 cases, herbal medications accounted for 9 [1.5%]). 16083708
Seeff LB. Herbal hepatotoxicity. Clin Liver Dis 2007; 11: 577-96. (Review of HDS associated hepatotoxicity, with review of the literature and details of hepatic injury for black cohosh, chaparral, Chinese herbs, comfrey and pyrrolizidine alkaloids, germander, celandine, kava, mistletoe, pennyroyal, skullcap and valerian). 17723921
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including green tea extracts in 3, cascara in 2, and horse chestnut, copalchi, chitosan, senna, valerian, kava, phytosoy and biosoy in 1 case each). 19159172
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbals and dietary supplements, prominent agents being green tea, androgenic steroids, and miscellaneous Hydroxycut and Herbalife products). 18955056
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling and frequent underreporting of herbal use by patients. The regulation of HDS is under DSHEA which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs, and includes HDS; HDS induced liver injury is a growing problem and current accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 31 with increased liver enzymes, 26 with elevated aminotransferase levels, 22 with mixed liver reaction and 12 with hepatitis; agents implicated in causing liver injury included valerian, ginseng, green tea, and aloe vera). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut products). 20949552
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids). 21457433
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, and a discussion of the difficulties of causality attribution and appeal for publications to be more complete in presenting information on the liver injury and its link to herbal preparations). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury with specific discussion of Ayurvedic products, chaparral, Chinese herbals, germander, greater celandine, green tea, Herbalife and Hydroxycut products, kava, pennyroyal oil, pyrrolizidine alkaloids and herb-drug interactions). 23121117
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances). 23510966
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity with specific focus on ephedra, germander, kava, chaparral, black cohosh, greater celandine, and Herbalife, Hydroxycut and Lipokinetix products). 22477279
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment). 24099027
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea extract). 24918129
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis 2014; 46: 264-9. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]). 24315480
de Oliveira AV, Rocha FT, Abreu SR. Acute liver failure and self-medication. Arq Bras Cir Dig 2014; 27: 294-7. (Review of published literature on acute liver failure associated with self-medication identified cases related to acetaminophen, GTE, linoleic acid, rhamnus purshianus [Fitosoja] and usnic acid). 25626943
Teschke R, Zhang L, Melzer L, Schulze J, Eickhoff A. Green tea extract and the risk of drug-induced liver injury. Expert Opin Drug Metab Toxicol 2014; 10: 1663-76. (Review of literature on whether green tea intake might increase the risk of liver injury from other drugs, via drug-herb interactions, concludes that there is no evidence that it does). 25316200
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract). 25043597
Rossi S, Navarro VJ. Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol 2014; 12: 1069-76. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality). 23924877
Navarro VJ, Lucena MI. Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis 2014; 34: 172-93. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment). 24879982
Korth C. Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract 2014; 27: 567-72. (Review of liver injury due to selected HDS discusses the literature implicating kava, green tea, germander, pyrrolizidine alkaloids and Herbalife products). 25546878
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-532.e3. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver). 25500423
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol 2015; 89: 851-65. (Extensive review of liver injury due to HDS). 25680499
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea extract). 25754159
Zheng EX, Navarro VJ. Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol 2015; 3: 93-8. (Review of literature on liver injury due to HDS products used for weight loss, focusing upon the case series of liver injury attributed to green tea as well as the commercial products that appear to contain it such as Herbalife and Hydroxycut, the injury of which was predominantly hepatocellular (acute hepatitis-like) and had a significant mortality rate). 26357638
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase). 26950122
Marcus DM. Dietary supplements: What's in a name? What's in the bottle? Drug Test Anal 2016; 8 (3-4): 410-2. (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident"). 27072845
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017;107:449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. 2017;107:472–501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 46 published cases of green tea associated liver injury and concludes that green tea may warrant a warning label). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient nutrition supplements [MINS]). 27842768
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products). 28555362
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products and challenges for future research concludes that stronger regulations are needed to address the increasing number of cases of HDS induced liver injury, particularly those linked to use of multiingredient dietary supplements). 27677775

## INTERNET SITES WITH RELIABLE HDS INFORMATION

Internet searches will identify hundreds of websites with information on specific botanicals and nutritional supplements, but the quality of the information varies enormously and many websites offer only anecdotal and unreliable testimonies to the benefits and offers for sale of the HDS. Fairly reliable and unbiased information on HDS can be obtained from the following US Government supported websites.

https://www.ods.od.nih.gov/ (The health information website of the Office of Dietary Supplements in the Office of the Director, National Institutes of Health)

https://www.nccih.nih.gov/health/supplements/wiseuse.htm (Information website of the National Center for Complementary and Integrative Health, National Institutes of Health)

https://www.nlm.nih.gov/medlineplus/druginfo/herb_All.html (Website of the National Library of Medicine’s MedlinePlus)